# Centella asiatica

## OVERVIEW

### Introduction

Centella asiatica, commonly known as gotu kola or Asian pennywort, is a herbaceous, flowering, perennial plant native to tropical areas of Southeast Asia and Australia and used as a food as well as in traditional medicine. While generally regarded as safe, Centella has been linked to rare instances of clinically apparent acute liver injury with jaundice.

### Background

Centella also known as gotu kola, tiger grass or Indian pennywort is made from fresh or dried leaves of Centella asiatica a creeping herbaceous, flowering plant native to tropical swampy areas of Southeast Asia and Australia but now found in many tropical and subtropical areas of the world. It is eaten as a vegetable and in salads and has been used for centuries in traditional Ayurvedic and Chinese medicine for a large variety of conditions. Centella extracts contain more than 100 constituents including polyacetylenes, flavonoids, flavones, sterols and lipids. The active ingredients are thought to be the pentacyclic triterpenoid glycosides, asiaticoside, centelloside, and madecassoside, and their aglycones, asiatic acid and madecassic acid. In vitro and in vivo studies suggest that these triterpenoids have anxiolytic, antiinflammatory, antioxidant, antiulcer, anticancer, neuroprotective, and wound healing properties. In traditional medicine, gotu kola has been used to treat a wide variety of conditions including minor wounds, psoriasis, cellulitis, chronic venous insufficiency, ulcers, hypertension, bronchitis, asthma, kidney disorders, urethritis, edema, diabetic microangiopathy, obesity, leprosy, smallpox, syphilis, and miscellaneous liver, kidney, pulmonary, and heart diseases. It is purported to promote immune function, to extend longevity, and to boost memory and cognitive function. However, none of these properties have been proven in prospective, controlled trials in humans, and Centella asiatica is not approved in the United States as therapy of any medical condition. Nevertheless, it is widely available as capsules, tablets, powders, solutions, and skin creams in over-the-counter herbal products. The typical oral dose is 60 to 120 mg daily of purified extracts, but may be 600 to 1800 mg daily of capsules or powders of dried leaves. Centella has few if any adverse events and no known proven severe adverse effects. In small trials, Centella asiatica extracts have appeared to be well tolerated with only mild, transient, and nonspecific adverse effects (headache, dizziness, bloating, diarrhea, nausea), which often have been similar in frequency among persons receiving placebo or alternative treatments. Rare instances of allergic reactions have been reported, particularly with topical therapy of skin diseases and wounds. Hepatotoxicity has also been reported but is very rare.

### Hepatotoxicity

Centella extracts have not been linked to serum enzyme elevations during therapy, although there have been few prospective studies in humans that have reported on laboratory test results during treatment. Nevertheless, rare instances of acute and symptomatic liver injury have been published, including a case series in 2008 of three Argentinian women who developed liver injury with jaundice after use of centella for weight loss (Case 1) and a single short case report from Switzerland in 2011 after its oral use for acne. The time to onset ranged from 3 to 8 weeks and the injury was described as hepatocellular, resolving completely within 1 to 2 months after stopping. Immunoallergic and autoimmune features were present in some cases. The possibility of contamination or presence of other potential hepatotoxins in the commercial products was not ruled out in the clinical reports of hepatotoxicity of centella.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of liver injury

The mechanism of liver injury attributed to Centella asiatica is not known, but the rare events suggest idiosyncratic, perhaps immune mediated injury due to one of the many components of the herb or one of its metabolites.

### Outcome and Management

Gotu kola hepatotoxicity is generally self-limited and only mild-to-moderate in severity. Appearance of clinically evident liver injury developing during therapy should lead to prompt withdrawal of the herbal product. Rechallenge should be avoided.

## CASE REPORT

### Case 1. Acute granulomatous hepatitis developing during weight loss treatment with Centella asiatica. (1)

A 61 year old previously healthy woman developed abdominal pain, arthralgias, and weakness followed by dark urine and jaundice after taking tablets of Centella asiatica for 30 days as a weight loss agent. On examination she was jaundiced and had tender hepatomegaly. Laboratory tests (Table) showed marked elevations of serum ALT and AST (30 and 26 times the upper limit of normal [ULN]) with mild elevations in alkaline phosphatase (1.7 times ULN) and bilirubin (4.2 mg/dL). Viral serology showed no evidence of hepatitis A, B or C, while autoantibody testing showed high titers of SMA (1:160) and AMA (1:320) with no detectable ANA or anti-LKM, and normal total globulin levels. Liver ultrasound was normal. A liver biopsy showed an acute hepatitis with granulomas. She was treated with ursodiol and recovered. Two months later all laboratory results were normal or negative including SMA and AMA. She did well until 7 months later when she restarted Centella asiatica for two weeks when she developed pain, weakness and jaundice again. Laboratory results were similar to those with the first episode but ANA, SMA and AMA were still negative. A repeat liver biopsy again showed acute hepatitis with granulomatous changes. She was treated with a course of prednisone and ursodiol and again improved.

#### Key Points

Medication: | Centella asiatica
Pattern: | Hepatocellular (R=17.6)
Severity: | 3+ (jaundice, hospitalized)
Latency: | 30 days initially, 14 days on re-exposure
Recovery: | 1-2 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
1 month | 0 | 1193 | 503 | 4.2 | SMA 1:160, AMA 1:320
| < 1 week | Liver biopsy: acute hepatitis with granulomatous changes
3 months | 1 month | 18 | 191 | 1.2 | SMA & AMA negative
0 | 0 | Restarts Centella asiatica
2 weeks | 0 | 413 | 383 | 2.8 | ANA, SMA & AMA negative
| < 1 week | Liver biopsy: acute hepatitis with granulomatous changes
1.5 months | 1 month | 27 | 238 | 0.6 | Ursodiol & prednisone stopped
8 years | 8 years | Laboratory values remained normal during follow up
Normal Values | | <40 | <301 | <1.2

#### Comment

A dramatic case of an immunoallergic acute hepatitis arising in an otherwise healthy woman taking a commercial weight loss product said to be Centella asiatica. The clinical history, laboratory tests, liver biopsy, and recurrence on re-exposure provide convincing evidence of drug induced liver injury from the herbal product. At issue is whether the product consisted of Centella asiatica only. The history could also be consistent with other better known herbal causes of acute liver injury such as ephedra, chaparral, germander, garcinia, or green tea. The product name, concentration of centella, number of tablets taken daily, chemical analysis, and even product label were not provided. After these 3 cases from a single referral center in Mendoza, Argentina in 2005, there have been no published case series of injury from Centella asiatica and only a single case report from Switzerland in 2011. Furthermore, the large series of herbal and dietary supplement induced liver injury from around the world, there have been no further described cases.

Other Names: Gotu kola, Asian pennywort, spadeleaf, coinwort, tiger grass, Brahmi, Centella

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Centella asiatica – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Asiaticoside | 16830-15-2 | C48-H78-O
Madecassoside | 34540-22-2 | C48H78O20

* Major pentacyclic triterpenoid glycosides found in Centella asiatica.

## CITED REFERENCES

1 Jorge OA, Jorge AD. Hepatotoxicity associated with the ingestion of Centella asiatica. Rev Esp Enferm Dig. 2005;97:115-24.15801887

## SELECTED ANNOTATED BIBLIOGRAPHY

References updated: 24 April 2024

Abbreviation: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but neither Centella asiatica or gotu kola are mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbals does not mention gotu kola).
Gotu kola (Centella asiatica). PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp 400-404. (Compilation of short monographs on herbal medications and dietary supplements mentions allergic contact dermatitis and infertility but not ALT elevations or hepatotoxicity).
Electronic Code of Federal Regulations. Title 21. Part 182. Substances Generally Recognized As Safe. Available at: https://www.accessdata.fda.gov/scripts/cdrh/cfdocs/cfcfr/CFRSearch.cfm?CFRPart=182 (Listing of botanical and herbal products that are “generally recognized as safe” (GRAS) according to FDA criteria which permits them to be sold as over-the-counter supplements without prior proof of safety and efficacy).
Bradwejn J, Zhou Y, Koszycki D, Shlik J. A double-blind, placebo-controlled study on the effects of Gotu Kola (Centella asiatica) on acoustic startle response in healthy subjects. J Clin Psychopharmacol. 2000;20:680-4. (Among 40 healthy adult volunteers given a single 12 gram oral dose of gotu kola or placebo in grape juice, the acute startle response decreased more in those given the herb [-68% vs -29%], while pulse, blood pressure and mood ratings [anxiety, depression] did not change; no mention of hepatotoxicity and laboratory tests were not done). 11106141
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were specifically attributed to a product containing gotu kola). 15390328
Jorge OA, Jorge AD. Hepatotoxicity associated with the ingestion of Centella asiatica. Rev Esp Enferm Dig. 2005;97:115-24. (3 Argentinian women developed jaundice 30, 20, and 60 days after starting Centella asiatica for weight loss [bilirubin 4.3, 19.9, and 3.9 mg/dL, ALT 1193, 1694, and 324 U/L, Alk P 503, 472, and 484 U/L], biopsies showing hepatitis with granulomas and zone 3 necrosis, high titers of autoantibodies found in one case [Case 1 above], all resolving completely with 1-2 months of stopping). 15801887
Chitturi S, Farrell GC. Hepatotoxic slimming aids and other herbal hepatotoxins. J Gastroenterol Hepatol. 2008;23:366-73. (Review of liver injury from herbal agents taken for weight loss mentions the 3 cases due to Centella asiatica as reported by Jorge [2005]). 18318821
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by "natural remedies": an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to gotu kola). 19159172
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling, and the frequent underreporting of herbal use by patients. Regulation of HDS is under DSHEA, which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs and includes HDS; HDS induced liver injury is a growing problem and currently accounts for at least 10% of cases of acute liver injury due to medications). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no mention of gotu kola or Centella asiatica). 19650152
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to gotu kola). 20949552
Gohil KJ, Patel JA, Gajjar AK. Pharmacological Review on Centella asiatica: A potential herbal cure-all. Indian J Pharm Sci. 2010;72:546-56. (Review of the botany and possible mechanisms of action of Centella asiatica extracts based upon laboratory studies in rodents and clinical trials in humans states that it “has no know toxicity in recommended doses” and that side effects are rare but may include skin allergy, headache, stomach upset, nausea, dizziness, and drowsiness particularly at high doses, and that it should not be used for more than 6 weeks). 21694984
Dantuluri S, North-Lewis P, Karthik SV. Gotu Kola induced hepatotoxicity in a child - need for caution with alternative remedies. Dig Liver Dis. 2011;43:500. (15 year old female developed abdominal pain 6 weeks after starting gotu kola for acne [bilirubin 1.8 mg/dL, ALT 319 rising to 3222 U/L, GGT 39 U/L, INR 2.7], improving rapidly upon stopping). 21334992
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, mentions 3 cases attributed to gotu kola as reported by Jorge [2005]). 22928722
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a product containing Centella asiatica). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea, and none were attributed to Centella asiatica or gotu kola [see also Navarro et al Hepatology 2014]). 25754159
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: 537. (Listing of published cases of liver injury from HDS products does not mention or list gotu kola or Centella asiatica). 27070596
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107: 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, mentions 4 cases attributed to gotu kola, 3 as reported by Jorge [2005] and 1 by Dantuluri [2011]) . 27402097
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. Liver injury from herbal and dietary supplements. Hepatology 2017; 65: 363-73. (Review of the problems of liver injury and HDS products, mentions that multiingredient dietary supplements account for the major of cases but does not mention a product with gotu kola as a component). 27677775
Haslan H, Suhaimi FH, Das S. Herbal supplements and hepatotoxicity: a short review. Nat Prod Commun. 2015;10:1779-84. (Review of liver injury due to herbal supplements mentions the 3 cases of jaundice caused by Centella asiatica as reported by Jorge [2005]). 26669124
Santos G, Gasca J, Parana R, Nunes V, Schinnoni M, Medina-Caliz I, Cabello MR, Lucena MI, et al. Profile of herbal and dietary supplements induced liver injury in Latin America: A systematic review of published reports. Phytother Res. 2021;35:6-19. (Review of reports of liver injury due to herbal supplements reported from Latin America lists the 3 cases of hepatitis attributed to Centella asiatica reported by Jorge from Argentina [2005]). 32525269
Torbati FA, Ramezani M, Dehghan R, Amiri MS, Moghadam AT, Shakour N, Elyasi S, et al. Ethnobotany, phytochemistry and pharmacological features of Centella asiatica: a comprehensive review. Adv Exp Med Biol. 2021;1308:451-499. (Review of the chemistry, possible mechanisms of action, and clinical uses of Centella asiatica; mentions the cases of hepatotoxicity published by Jorge [2005] but cites studies in rats showing no abnormalities in ALT or AST even with the highest doses used). 33861456
Biswas D, Mandal S, Chatterjee Saha S, Tudu CK, Nandy S, Batiha GE, et al. Ethnobotany, phytochemistry, pharmacology, and toxicity of Centella asiatica (L.) Urban: A comprehensive review. Phytother Res. 2021;35:6624-6654. (Review of the phytochemistry, pharmacology and toxicity of Centella asiatica mentions that it is cultivated is semi-aquatic environments and is used as a food as well as medicinal herb to treat minor wounds, eczema, ulcers, diarrhea, measles, jaundice, asthma, diabetes, toothache, smallpox, leprosy, syphilis, dementia, and digestive disorders, and that it is well tolerated in human subjects with no major undesirable effects, but also mentions the 3 cases of jaundice reported by Jorge [2005]). 34463404
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3]; Centella asiatica and gotu kola are not mentioned). 33434654
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; Centella asiatica is listed as implicated in 3 cases as described by Jorge [2005]). 34307603
Bandopadhyay S, Mandal S, Ghorai M, Jha NK, Kumar M, Ghosh A, et al. Therapeutic properties and pharmacological activities of asiaticoside and madecassoside: A review. J Cell Mol Med. 2023;27:593-608. (Review of the phytochemistry and the biologic and clinical effects of asiaticoside and madecassoside, major triterpenoid glycosides of Centella asiatica, including neuroprotection, dermatologic healing, UV protection, pulmonary, renal, and liver protection, immunomodulatory, antiinflammatory, and antiallergic activities; no discussion of toxicity). 36756687

## OTHER REFERENCE LINKS

Recent References on Centella asiatica: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Centella%20asiatica+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Centella asiatica: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Centella%20asiatica)